# Efavirenz

## OVERVIEW

### Introduction

Efavirenz is a nonnucleoside reverse transcriptase inhibitor used in combination with other agents in the therapy of human immunodeficiency virus (HIV) infection. Efavirenz is associated with a low rate of serum enzyme elevations during therapy and is an uncommon, but well established cause of clinically apparent acute liver injury.

### Background

Efavirenz (ef" a vir' enz) is an antiretroviral agent that acts by noncompetitive binding to and inhibition of the HIV reverse transcriptase. Efavirenz is a nonnucleoside reverse transcriptase inhibitor and is similar to nevirapine in its mechanism of action, but has little or no structural similarity. Efavirenz was approved for use in the United Sates in 1998 and is currently used in many antiretroviral regimens. Efavirenz is indicated for the treatment of HIV infection in combination with other antiretroviral agents. Efavirenz is available generically and under the brand name Sustiva in capsules of 50 and 200 mg and in tablets of 600 mg. Efavirenz is also available in fixed combination with emtricitabine (200 mg) and tenofovir (300 mg) under the brand name Atripla. The recommended dose of efavirenz in adults is 600 mg orally once daily. Common side effects include headache, dizziness, insomnia, fatigue and skin rashes (~25%). Rare, but potentially severe adverse effects include psychiatric and neurologic symptoms, convusions, immune reconstitution syndrome, lipodystrophy and severe hypersensitivity reactions including Stevens Johnson syndrome.

### Hepatotoxicity

Serum aminotransferase elevations above 5 times the upper limit of normal occur in 1% to 8% of patients on efavirenz, and this rate is higher in patients who have HCV coinfection. Clinically apparent hepatotoxicity due to efavirenz is rare, but many convincing cases have been published. The liver injury is usually immunoallergic in pattern and arises within 1 to 8 weeks of starting therapy. Signs of hypersensitivity are less common than with nevirapine hepatotoxicity, but symptoms can include rash, fever, and eosinophilia and sometimes facial edema, lymphadenoapthy and lymphocytosis (Cases 1 and 2). Autoantibody formation is rare. The serum enzyme pattern is variable, typically cholestatic or mixed, but sometimes hepatocellular, these cases being more severe, likely to show submassive necrosis on liver biopsy and associated with a high fatality rate. In general, however, recovery is rapid upon stopping therapy.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the clinically apparent hepatotoxicity from efavirenz appears to be hypersensitivity. Features such as eosinophilia, skin rash and biopsy findings suggest that the injury is due to an immunoallergic reaction. Efavirenz is metabolized by the cytochrome P450 system including CYP 3A and 2B6 and has significant drug-drug interactions with drugs that alter or are metabolized by the same enzymes.

### Outcome and Management

The severity of the liver injury due to efavirenz ranges from mild and transient enzyme elevations to acute hepatocellular jaundice and even fulminant liver failure and death. Typically, improvements start within a few days of stopping efavirenz and full recovery is expected within 2 to 8 weeks. Corticosteroids are often used and appear to help reverse fever and rash, but their role in ameliorating the liver disease is uncertain. Rechallenge may lead to recurrence and should be avoided. Despite the similarity in causing immunoallergic hepatitis, there does not seem to be cross sensitivity to the hepatic injury between efavirenz and nevirapine or other nonnucleoside reverse transcriptase inhibitors, although there may be cross reactivity in occurrence of rash.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Nonnucleoside Reverse Transcriptase Inhibitors: Delavirdine, Doravirine, Etravirine, Nevirapine, Rilpivirine

## CASE REPORTS

### Case 1. Efavirenz-induced hypersensitivity reaction with hepatitis and rash.

[Modified from: Leung JM, O'Brien JG, Wong HK, Winslow DL. Efavirenz-induced hypersensitivity reaction manifesting in rash and hepatitis in a Latino male. Ann Pharmacother 2008; 42: 425-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/18252833)]

A 30 year old man newly diagnosed with HIV infection [CD4: 20 cells/mm3; HIV-1 RNA: 32,388 copies/mL] developed skin rash and fever 11 days after starting the combination of efavirenz (600 mg), tenofovir (300 mg), and emtricitabine (200 mg) once daily. He was also being treated with pyrimethamine (75 mg/day) and sulfadiazine (6 g/day) for toxoplasmosis and azithromycin and fluconazole for prophylaxis against opportunistic infections, all of which had been started four weeks before the antiretrovirals. He denied alcohol use or exposures to viral hepatitis. Physical examination showed a generalized erythematous rash. Therapy was continued. One week later he complained of abdominal pain, nausea and fever, and blood tests showed marked elevations in serum aminotransferase levels (Table). All medications were stopped. Serum enzyme elevations peaked 5 days after stopping antiretroviral therapy and he recovered slowly but completely. Serum lactate levels were normal, and tests for viral hepatitis A, B and C and autoantibodies were negative. He was subsequently treated with tenofovir, emtricitabine and atazanavir without recurrence of the liver abnormalities.

#### Key Points

Medication: | Efavirenz (600 mg daily)
Pattern: | Cholestatic (R=1.9)
Severity: | 4+ (jaundice, hospitalization, and coagulopathy)
Latency: | 11 days to onset of rash, 18 days to onset of jaundice
Recovery: | Yes, time to recovery not available
Other medications: | Pyrimethamine, sulfadiazine, azithromycin, fluconazole, tenofovir, emtricitabine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
18 days | | 699 | 1073 | 3.0
3 weeks | 0 | 1181 | 1362 | 4.2 | Temperature 39.5^o^ C
| 5 days | 2132 | 760 | 10.0 | Ammonia 119; INR 2.6
4 weeks | 1 week | 488 | 840 | 7.5
Normal Values | | <40 | <117 | <1.2

* Values estimated from Figure 1.

#### Comment

The sudden onset of rash followed by fever and a cholestatic hepatitis within 2 to 3 weeks of starting efavirenz suggests an immunoallergic form of drug induced liver disease. A similar type of liver injury can occur with sulfadiazine, but the timing was better for efavirenz. A possible role for tenofovir and emtricitabine appeared unlikely because of the lack of recurrence with rechallenge.

### Case 2. Efavirenz-induced acute eosinophilic hepatitis.

[Modified from: Verdon R, Six M, Rousselot P, Bazin C. Efavirenz-induced acute eosinophilic hepatitis. J Hepatol 2001; 34: 783-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/11434632)]

A 45 year old man on long term antiretroviral therapy developed skin rash, fever and abdominal pain 4 weeks after switching from indinavir to efavirenz on top of a chronic regimen of zidovudine and lamivudine. Serum bilirubin was normal, but aminotransferase and alkaline phosphatase levels were elevated (Table). The patient was known to have had antibody to hepatitis C, but serum aminotransferase levels were normal when efavirenz was started and HCV RNA was not detected in serum on multiple occasions. He had no history of liver disease and did not drink alcohol. Tests for hepatitis A and B and for autoantibodies were normal or negative. An ultrasound of the abdominal showed no evidence of obstruction. Liver biopsy showed hepatocellular injury with frequent eosinophils. Improvement began within days of stopping efavirenz, and tests were normal 5 weeks later.

#### Key Points

Medication: | Efavirenz (600-1200 mg daily)
Pattern: | Mixed (R=2.9), later cholestatic
Severity: | 1+ (symptomatic, no frank jaundice)
Latency: | 4 weeks
Recovery: | Yes, complete in 4-5 weeks
Other medications: | Zidovudine, lamivudine, indinavir

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 16 | 65 | 1.5 | Efavirenz started
4 weeks | 0 | 718 | 684 | 1.1 | Efavirenz stopped
5 weeks | 1 week | 141 | 928 | 0.7 | Eosinophils: 1110/µL
6 weeks | 2 weeks | 25 | 246 | 0.6
2 months | 5 weeks | 19 | 156 | 0.8
Normal Values | | <38 | <105 | <1.2

#### Comment

The onset of rash and liver injury within 4 weeks of starting efavirenz in a patient on long term zidovudine and lamivudine is highly suggestive of a hypersensitivity reaction with an accompanying anicteric hepatitis due to efavirenz. This case also had biopsy findings which suggested an allergic nature of the toxicity of this drug. The role of hepatitis C was ruled out by the absence of detectable HCV RNA before, during and after the onset of injury. Recovery was rapid upon stopping therapy and corticosteroids were not used.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Efavirenz – Sustiva®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=efavirenz)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Efavirenz | 154598-52-4 | C14-H9-Cl-F3-N-O2 | Efavirenz Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2018

Abbreviations used: NNRTI, nonnucleoside reverse transcriptase inhibitors; TMP/SMZ, trimethoprim with sulfamethoxazole.

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents, including the nonnucleoside reverse transcriptase inhibitors [NNRTIs]).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1623-64. (Textbook of pharmacology and therapeutics).
http://aidsinfo.nih.gov/guidelines. (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Adkins JC, Noble S. Efavirenz. Drugs 1998; 56: 1055-64. (Review of structure, pharmacology, antiviral resistance, efficacy and safety of efavirenz; no discussion of hepatotoxicity). 9878993
Havlir DV, Lange JM. New antiretrovirals and new combinations. AIDS 1998; 12 Suppl A: S165-74. (Review of newy approved agents, including nelfinavir, nevirapine, delaviridine, efavirenz and abacavir; most significant toxicities discussed include diarrhea for nelfinavir, rash and hepatitis for nevirapine, rash for delavirdine; little information available on toxicities of other agents). 9632999
Moyle G. Efavirenz; shifting the HAART paradigm in adult HIV-1 infection. Expert Opinion on Investigational Drugs 1999; 8: 473-86. (Review of structure, activity, pharmacology, efficacy and safety of efavirenz; ALT elevations occur in 2-3% of both efavirenz and control groups using comparative agents). 15992093
Clarke S, Harrington P, Barry M, Mulcahy F. The tolerability of efavirenz after nevirapine-related adverse events. Clin Infect Dis 2000; 31: 806-7. (Among 8 patients stopping nevirapine because of toxicity including 3 with ALT elevations [>5 times ULN], none developed liver toxicity and only one had any symptoms [facial edema] after switching to efavirenz). 10824944
Bossi P, Colin D, Dricaire F, Caumes E. Hypersensitivity syndrome associated with efavirenz therapy. Clin Infect Dis 2000; 30: 227-8. (44 year old woman developed rash 20 days after starting efavirenz, lamivudine and stavudine, followed by fever and jaundice [bilirubin 16.5 mg/dL, ALT 458 U/L, 9% eosinophils], resolving rapidly with corticosteroid therapy). 10619772
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. Hepatotoxicity associated with antiretroviral therapy in adults infected with human immunodeficiency virus and the role of hepatitis C or B virus infection. JAMA 2000; 283: 74-80. (Among 298 patients with HIV infection, ALT elevations above 5 times ULN occurred in 10.4% per year during antiretroviral treatment; factors associated with ALT elevations included ritonavir [27.3%] and coinfection with either HCV or HBV; ALT with bilirubin elevations occurred in 3 patients; 2 on indinavir and all 3 with coinfection). 10632283
Velasco M, Guijarro C. Elevated liver enzymes following initiation of antiretroviral therapy. JAMA 2000; 283: 2526-7. (Letter in response to Sulkowski et al. [JAMA 2000] pointing out that antiretroviral therapy can cause immune reconstitution and flares of hepatitis B or C, which may be misdiagnosed as hepatotoxicity). 10815112
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. Elevated liver enzymes following initiation of antiretroviral therapy JAMA 2000; 283: 2526-7. (Reply to Velasco and Guijarro pointing at that the majority of the ALT elevations described could not be attributed to immune reconstitution). 10815113
Soriano V, Dona C, Barreiro P, Gonzalez-Lahoz J. Is there cross-toxicity between nevirapine and efavirenz in subjects developing rash. AIDS 2000; 14: 1672-3. (Retrospective review, only 1 of 8 patients with rash on nevirapine developed rash on efavirenz; no mention of hepatic cross reactions). 10983663
Verdon R, Six M, Rousselot P, Bazin C. Efavirenz-induced acute eosinophilic hepatitis. J Hepatol. 2001; 34: 783-5. (45 year old man developed rash and abdominal pain 4 weeks after starting efavirenz [bilirubin 18.0 mg/dL, ALT 141 U/L, Alk P 684 U/L], resolving within 4 weeks of stopping: Case 2). 11434632
Hill JB, Sheffield JS, Zeeman GG, Wendel GD Jr. Hepatotoxicity with antiretroviral treatment of pregnant women. Obstet Gynecol 2001; 98: 909-11. (Two cases, 28 year old woman on zidovudine, lamivudine and efavirenz developed jaundice at 18 weeks of pregnancy [bilirubin 20.4 mg/dL, ALT 421 U/L], remaining jaundiced until delivery at 27 weeks, resolving within 5 months of stopping; 22 year old woman started on lamivudine, zidovudine and nelfinavir at 14 weeks of pregnancy and developed jaundice 10 weeks later [bilirubin 8.9 mg/dL, ALT 1598 U/L], progressing to acute liver failure and death). 11704198
Clark S, Creighton S, Portmann B, Taylor C, Wendon J, Cramp M. Acute liver failure associated with antiretroviral treatment for HIV: a report of six cases. J Hepatol 2002; 36: 295-301. (6 patients with HIV infection who developed acute liver failure on stavudine [n=5], lamivudine [n=3], didanosine [n=2], saquinavir [n=2], efavirenz [n=2], nevirapine [n=2], or nelfinavir, delaviridine or zidovudine [n=1] for 1-3 months [peak bilirubin 2.7-32 mg/dL, AST 240-8650 U/L, Alk P 122-191 U/L]; 2 had signs of hypersensitivity, 2 had hepatitis B and 5 died; autopsies showed massive necrosis and one had massive steatosis). 11830344
Dybul M, Fauci AS, Bartlett JG, Kaplan JE, Pau AK; Panel on Clinical Practices for the Treatment of HIV. Guidelines for using antiretroviral agents among HIV-infected adults and adolescents. Recommendations of the Panel on Clinical Practices for Treatment of HIV. MMWR Recomm Rep 2002; 51 (RR-7): 1-55. (Recommendations on use of antiretroviral agents for HIV infection including indications, efficacy, need for monitoring and side effects including hepatotoxicity). 12027060
Sulkowski MS, Thomas DL, Mehta SH, Chaisson RE, Moore RD. Hepatotoxicity associated with nevirapine or efavirenz-containing antiretroviral therapy: role of hepatitis C and B infections. Hepatology 2002; 35: 182-9. (Prospective analysis of 568 patients, ALT levels above 5 ULN occurred in 16% on nevirapine and 8% on efavirenz, only 1/3rd in first 12 weeks, usually associated with HBV or HCV coinfection [69%] or concurrent protease inhibitor therapy [82%]; no recurrence on switching from one to the other). 11786975
Abrescia N, D'Abbraccio M, Figoni M, Busto A, Butrico E, De Marco M, Viglietti R. Fulminant hepatic failure after the start of an efavirenz-based HAART regimen in a treatment-naive female AIDS patient without hepatitis virus co-infection. J Antimicrob Chemother 2002; 50: 763-5. (30 year old woman developed rash after 7 and jaundice after 10 days of combination antiretroviral therapy with stavudine, zidovudine, lamivudine and efavirenz [bilirubin 12.6 mg/dL, ALT 6 times ULN], subsequently worsening and dying 1 week later despite stopping therapy promptly). 12407142
Pulido F, Torralba M. NNRTI hepatotoxicity: efavirenz versus nevirapine. J HIV Ther 2002; Suppl 2: S3-16. (Review of hepatotoxicity of all antiretrovirals with focus on NNRTIs). 12735215
Law WP, Dore GJ, Duncombe CJ, Mahanontharit A, Boyd MA, Ruxrungtham K, Lange JM, et al. Risk of severe hepatotoxicity associated with antiretroviral therapy in the HIV-NAT Cohort, Thailand, 1996-2001. AIDS 2003; 17: 2191-9. (Among 692 patients in 8 controlled trials in Thailand, rate of ALT elevations above 5 times ULN was 6.1/100 patient years overall; in multivariate analysis, risk factors were HBV [RR=3.9], HCV [3.0], and use of NNRTIs [6.8], rate with nevirapine [18.6/100 person-years] higher than efavirenz [2.4]). 14523276
Ena J, Amador C, Benito C, Fenoll V, Pasquau F. Risk and determinants of developing severe liver toxicity during therapy with nevirapine-and efavirenz-containing regimens in HIV-infected patients. Int J STD AIDS 2003; 14: 776-81. (Retrospective review of 136 patients treated with NNRTI combinations, 48% had ALT elevations which were >5 times ULN in 20%; risk factors were alcohol use, HCV infection and 4 drug regimens; 3 of 17 patients with ALT elevations on nevirapine redeveloped ALT elevations on restarting; 2 patients with jaundice, but both had HCV infection and were exposed to other hepatotoxins). 14624743
Kontorinis N, Dieterich D. Hepatotoxicity of antiretroviral therapy. AIDS Rev 2003; 5: 36-43. (Review of hepatotoxicity of antiretroviral drugs including the definition of hepatotoxicity used in early antiretroviral studies; grade 1=1.25-2.5, grade 2=2.5-5, grade 3=5-10 and grade 4=>10 times ULN or baseline ALT values). 12875106
Ogedegbe AO, Sulkowski MS. Antiretroviral-associated liver injury. Clin Liver Dis 2003; 7: 475-99. (Review of hepatotoxicity of antiretrovirals; ALT elevations above 5 times ULN reported in 7% with zidovudine, 16% didanosine, 9-13% stavudine, <1% lamivudine, tenofovir and abacavir, 3-10% protease inhibitors, 10% nevirapine and 8% efavirenz; recommends monitoring at 4 weeks and then every 12 weeks, stopping if ALT levels are >10 times ULN or if symptoms of liver injury are present, monitoring more closely if ALT levels are elevated). 12879995
Ofotokun I, Pomeroy C. Sex differences in adverse reactions to antiretroviral drugs. Top HIV Med 2003; 11: 55-9. (Review of sex differences in adverse events; higher frequency of mitochondrial toxicity and hypersensitivity in women than men). 12717043
Martín-Carbonero L, Núñez M, González-Lahoz J, Soriano V. Incidence of liver injury after beginning antiretroviral therapy with efavirenz or nevirapine. HIV Clin Trials 2003; 4: 115-20. (Retrospective analysis of 298 patients, ALT elevations >5 times ULN occurred in 12% of nevirapine vs 4% of efavirenz treated patients, more frequent with HCV coinfection, in women and in alcohol drinkers). 12671779
Manfredi R, Calza L, Chiodo F. Efavirenz versus nevirapine in current clinical practice: a prospective, open-label observational study. J Acquir Immune Defic Syndr 2004; 35: 492-502. (Comparison of 287 patients on efavirenz vs 258 on nevirapine in practice situation; similar efficacy but higher rate of ALT abnormalities with nevirapine [52% vs 18%]) and discontinuation because of liver toxicity [3.5% vs 0]). 15021314
Dieterich DT, Robinson PA, Love J, Stern JO. Drug-induced liver injury associated with the use of nonnucleoside reverse-transcriptase inhibitors. Clin Infect Dis 2004; 38 Suppl 2: S80-9. (Review of hepatotoxicity of nonnucleoside reverse transcriptase inhibitors; in 17 controlled trials of nevirapine, 10% of patients developed ALT or AST elevations above 5 times ULN and 5% had a symptomatic hepatic event). 14986279
Te HS. Cholestasis in HIV-infected patients. Clin Liver Dis 2004; 8: 213-28, viii-ix. (Review of causes of cholestasis in HIV infected patients, including antiretrovirals). 15062202
Abrescia N, D’Abbraccio M, Figoni M, Busto A, Maddaloni A, De Marco M. Hepatotoxicity of antiretroviral drugs. Curr Pharm Des 2005; 11: 3697-710. (Review of hepatotoxicity of antiretrovirals; major syndrome with nonnucleoside reverse transcriptase inhibitors is hypersensitivity). 16305505
Núñez M, Soriano V. Hepatotoxicity of antiretrovirals: incidence, mechanisms and management. Drug Saf 2005; 28: 53-66. (Review of liver toxicity of antiretrovirals). 15649105
Aranzabal L, Casado JL, Moya J, Quereda C, Diz S, Moreno A, Moreno L, et al. Influence of liver fibrosis on highly active antiretroviral therapy-associated hepatotoxicity in patients with HIV and hepatitis C virus coinfection. Clin Infect Dis 2005; 40: 588-93. (Among 107 patients with HIV-HCV coinfection and pretreatment liver biopsy; ALT elevations of >5 times ULN [or 3.5 times baseline] occurred in 38% with advanced fibrosis and 15% without fibrosis; higher rates of ALT elevations occurred with nevirapine and efavirenz therapy [13%]). 15712082
Verma S, Bhakta H, Nowain A, Pais S, Kanel G, Squires K, Squires K. Severe cholestatic liver injury days after initiating antiretroviral therapy in a patient with AIDS: drug toxicity or immune reconstitution inflammatory syndrome? Dig Dis Sci 2005; 50: 1813-7. (37 year old man with AIDS developed rash and fever one week after starting efavirenz and lopinavir/ritonavir and one day after restarting azithromycin, trimethoprim/sulfamethoxazole (TMP/SMS), one week later becoming jaundiced [bilirubin 0.4 rising to 9.9 mg/dL, ALT 20 to 103 U/L, Alk P 70 to 700 U/L], values normalizing within a few weeks of stopping, but recurring with jaundice after 2 rechallenges using same antiretroviral regimen without TMP/SMS). 16187179
Rotger M, Colombo S, Furrer H, Bleiber G, Buclin T, Lee BL, Keiser O, et al.; Swiss HIV Cohort Study. Influence of CYP2B6 polymorphism on plasma and intracellular concentrations and toxicity of efavirenz and nevirapine in HIV-infected patients. Pharmacogenet Genomics 2005; 15: 1-5. (Analysis of an allele of CYP 2B6, the major hepatic enzyme responsible for efavirenz and nevirapine metabolism; G516T was associated with higher drug levels for both agents, and higher tissue levels correlated with greater neuropsychiatric side effects). 15864119
Sanne I, Mommeja-Marin H, Hinkle J, Bartlett JA, Lederman MM, Maartens G, Wakeford C, et al. Severe hepatotoxicity associated with nevirapine use in HIV-infected subjects. J Infect Dis 2005; 191: 825-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2015717255) (In a prospective study, ALT elevations above 5 times normal occurred in 17% [66/385] of nevirapine vs 0% [0/83] of efavirenz treated patients, usually in the first 12 weeks, most had symptoms including rash, nausea and jaundice; two cases of acute liver failure and death on nevirapine).
Kappelhoff BS, van Leth F, Robinson PA, MacGregor TR, Baraldi E, Montella F, Uip DE, et al.; 2NN Study Group. Are adverse events of nevirapine and efavirenz related to plasma concentrations? Antivir Ther 2005; 10: 489-98. (Among 1077 patients receiving nevirapine or efavirenz, no association found between adverse events and plasma levels or pharmacokinetics, except for a slight correlation of higher efavirenz levels and ALT elevations). 16038474
Torti C, Lapadula G, Casari S, Puoti M, Nelson M, Quiros-Roldan E, Bella D, et al.; EPOKA-MASTER Study Group. Incidence and risk factors for liver enzyme elevation during highly active antiretroviral therapy in HIV-HCV co-infected patients: results from the Italian EPOKA-MASTER Cohort. BMC Infect Dis 2005; 5: 58. (Among 1038 HIV-HCV coinfected patients starting antiretroviral therapy, the risk of ALT elevations above 5 times ULN was 17.1/100 patient years in treatment naïve and 8.2 in treatment-experienced group; risk factors being baseline ALT levels and nonnucleoside reverse transcriptase inhibitor use). 16018804
Zhou J, Phanupak P, Kiertiburanakul S, Ditangco R, Kamarulzaman A, Pujary S; TREAT Asia HIV Observational Database. Highly active antiretroviral treatment containing efavirenz or nevirapine and related toxicity in the TREAT Asia HIV Observational Database. J Acquir Immune Defic Syndr 2006; 43: 501-3. (Analysis of 735 HIV-positive patients started on efavirenz- and 813 on nevirapine-containing regimens; 12 patients in both groups developed ALT >5 times normal but monitoring was irregular; no deaths from liver disease; no racial differences in rates of ALT elevations, HCV coinfection was a risk factor). 17099317
Buyse S, Vibert E, Sebagh M, Antonini T, Ichai P, Castaing D, Samuel D, et al. Liver transplantation for fulminant hepatitis related to nevirapine therapy. Liver Transpl 2006; 12: 1880-2. (38 year old woman with HIV infection developed acute liver failure 6 weeks after starting nevirapine plus zidovudine and lamivudine [bilirubin 11.2 mg/dL, ALT 12578 U/L, GGT 340 U/L], undergoing liver transplantation and tolerating efavirenz in follow up after transplant). 17133571
Ritchie MD, Haas DW, Motsinger AA, Donahue JP, Erdem H, Raffanti S, Rebeiro P, et al. Drug transporter and metabolizing enzyme gene variants and nonnucleoside reverse-transcriptase inhibitor hepatotoxicity. Clin Infect Dis 2006; 43: 779-82. (Case control study of 9 nevirapine and 4 efavirenz recipients who developed ALT above 5 times ULN on therapy vs 49 controls; found weak association with a MDR1 [p-glycoprotein: ABC B1] polymorphism). 16912956
Servoss JC, Kitch DW, Andersen JW, Reisler RB, Chung RT, Robbins GK. Predictors of antiretroviral-related hepatotoxicity in the adult AIDS Clinical Trial Group(1989-1999). J Acquir Immune Defic Syndr 2006; 43: 320-3. (Analysis of factors that predict “serious hepatotoxicity” in 9% of cohort of 8851 patients with HIV infection enrolled in trials of antiretroviral therapy; factors identified included baseline liver test abnormalities, HCV infection, and in subgroups, didanosine, nevirapine and stavudine). 16967041
Hofman P, Nelson AM. The pathology induced by highly active antiretroviral therapy against human immunodeficiency virus: an update. Curr Med Chem 2006; 13: 3121-32. (Review of pathology of adverse effects of antiretroviral agents with examples of mitochondrial liver injury and cholestasis). 17168701
Núñez M. Hepatotoxicity of antiretrovirals: incidence, mechanisms and management. J Hepatol 2006; 44(1 Suppl): S132-9. (Review of hepatotoxicity of antiretrovirals; elevations in ALT or AST above 5 times ULN occur in 2-18% of HIV-positive patients starting therapy, more frequent with HCV or HBV coinfection; combination of protease inhibitors with low dose ritonavir does not seem to increase risk; agents with highest risk are nevirapine and the nonnucleoside reverse transcriptase inhibitors). 16364487
Hoffmann C, Charalambous S, Thio CL, Martin DJ, Pemba L, Fielding KL, Churchyard GJ, et al. Hepatotoxicity in an African antiretroviral therapy cohort: the effect of tuberculosis and hepatitis B. AIDS 2007; 21: 1301-08. (Among 868 Africans with HIV infection, ALT elevations above 5 times ULN occurred in 7.7 per 100 person years with lamivudine, zidovudine and efavirenz; risk was increased by antituberculosis therapy [8.5 fold], HBsAg [3 fold] and low CD4 counts [1.9 fold]). 17545706
Bourlière M, Duclos-Vallée JC, Pol S. [Liver and antiretrovirals: hepatotoxicity, steatosis and monitoring of patients with liver disease] Gastroenterol Clin Biol 2007; 31: 895-905. French. (Review of hepatotoxicity of antiretrovirals in French discussing patterns of hypersensitivity reactions [nevirapine and abacavir], mitochondrial toxicity [zalcitabine, didanosine, stavudine and zidovudine], steatohepatitis [protease inhibitors with lipodystrophy], immune restoration [in patients with HIV-HBV or -HCV coinfection]; recommendations for management focusing on prevention and monitoring). 18166875
Jain MK. Drug-induced liver injury associated with HIV medications. Clin Liver Dis 2007; 11: 615-39, vii-viii. (Review of hepatotoxicity of antiretroviral medications; ALT elevations occur in 2-18% of patients, but often resolve spontaneously even without dose modification; classes of injury include hypersensitivity [nevirapine, efavirenz, abacavir], mitochondrial damage [stavudine, didanosine, zidovudine], flares of hepatitis B [lamivudine, emtricitabine, tenofovir], flares of hepatitis C [any potent regimen], idiosyncratic injury [ritonavir, nevirapine, efavirenz], and cholestatic hepatitis [many agents]). 17723923
Esser S, Helbig D, Hillen U, Dissemond J, Grabbe S. Side effects of HIV therapy. J Dtsch Dermatol Ges 2007; 5: 745-54. (Review of side effects of antiretroviral agents focusing on immune reconstitution syndrome, lipodystrophy, cutaneous skin reactions, hypersensitivity reactions [abacavir, nevirapine], hyperbilirubinemia [indinavir, atazanavir], local reactions [enfuvirtide] and hyperpigmentation [zidovudine, emtricitabine]). 17760894
Mussi-Pinhata MM, Rego MA, Freimanis L, Kakehasi FM, Machado DM, Cardoso EM, Read JS; NISDI Perinatal Protocol Study Group. Maternal antiretrovirals and hepatic enzyme, hematologic abnormalities among human immunodeficiency virus type 1-uninfected infants: the NISDI perinatal study. Pediatr Infect Dis J 2007; 26: 1032-7. (Liver enzyme elevations in newborns of HIV infected mothers on various antiretroviral regimens; infants whose mothers received protease inhibitors were more likely to have ALT elevations [odds ratio 1.9] similarly for nonnucleoside reverse transcriptase inhibitors [odds ratio 2.4] most elevations were mild and self-limited). 17984811
Mehta U, Maartens G. Is it safe to switch between efavirenz and nevirapine in the event of toxicity? Lancet Infect Dis 2007; 7: 733-8. (Review mentions that there is some evidence of cross sensitivity between nevirapine and efavirenz to skin rash, but not to hepatotoxicity; 11 patients in literature switched and no recurrence). 17961859
Rivero A, Mira JA, Pineda JA. Liver toxicity induced by non-nucleoside reverse transcriptase inhibitors. J Antimicrob Chemother 2007; 59: 342-6. (Review of liver toxicity of nevirapine and efavirenz, ALT elevations above 5 times ULN reported in 1-8% of efavirenz vs 4-16% of nevirapine recipients). 17255142
Lattuada E, Lanzafame M, Carolo G, Gottardi M, Concia E, Vento S. Does tenofovir increase efavirenz hepatotoxicity? AIDS 2008; 22: 995-6. (Three patients with HIV infection without hepatitis B or C on efavirenz therapy who developed ALT elevations 4-6 weeks after starting tenofovir; ALT 144, 186 and 392 U/L [previously normal], resolving with stopping tenofovir). 18453862
Medrano J, Barreiro P, Tuma P, Vispo E, Labarga P, Blanco F, Soriano V. Risk for immune-mediated liver reactions by nevirapine revisited. AIDS Rev 2008; 10: 110-5. (Review: Symptomatic hepatic events occur in ~5% of patients taking nevirapine, early hypersensitivity reactions occurring especially in women with CD4 counts >250 and with HBV or HCV infection. Late onset hepatotoxicity may be class effect [with efavirenz]). 18615121
Bae WH, Wester C, Smeaton LM, Shapiro RL, Lockman S, Onyait K, Thior I, et al. Hematologic and hepatic toxicities associated with antenatal and postnatal exposure to maternal highly active antiretroviral therapy among infants. AIDS 2008; 22: 1633-40. (Prospective monitoring found that only 1 of 69 infants born to antiretroviral treated mothers and none of 109 infants born to drug therapy unexposed mothers with HIV infection developed ALT elevations >5 times ULN during the first 7 months of life). 18670224
Sathia L, Obiorah I, Taylor G, Kon O, O’Donoghue M, Gibbins S, Walsh J, et al. Concomitant use of nonnucleoside analogue reverse transcriptase inhibitors and rifampicin in TB/HIV type 1-coinfected patients. AIDS Res Hum Retroviruses 2008; 24: 897-901. (Among 103 HIV infected persons with tuberculosis receiving rifampin, including 17 on nevirapine and 26 efavirenz, transient elevations in ALT occurred in 17%, but only 2 patients stopped therapy for ALT elevations above 5 times ULN, and both restarted antituberculosus therapy after ALT abnormalities resolved without recurrence). 18671475
Brück S, Witte S, Brust J, Schuster D, Mosthaf F, Procaccianti M, Rump JA, et al. Hepatotoxicity in patients prescribed efavirenz or nevirapine. Eur J Med Res 2008; 13: 343-8. (Among 151 patients starting efavirenz and 145 nevirapine, rates of ALT elevations were similar in the two groups; 6% vs 3.4% had ALT levels above 2.5 times ULN and 1.2% vs 2.1% had ALT above 5 times ULN; only predictive factor identified was HBsAg; no fatal cases). 18700192
Leung JM, O'Brien JG, Wong HK, Winslow DL. Efavirenz-induced hypersensitivity reaction manifesting in rash and hepatitis in a Latino male. Ann Pharmacother 2008; 42: 425-9. (30 year old man developed rash 11 days after starting tenofovir, emtricitabine and efavirenz for HIV infection, and jaundice and fever arose by day 18 [bilirubin 3.0 mg/dL, ALT 699 U/L, Alk P 1073 U/L], values peaking 5 days after stopping and ultimately resolving: Case 1). 18252833
Soriano V, Puoti M, Garcia-Gascó P, Rockstroh JK, Benhamou Y, Barreiro P, McGovern B. Antiretroviral drugs and liver injury. AIDS 2008; 22: 1-13. (Review of hepatotoxicity of antiretroviral drugs with recommendations on management: stopping therapy if symptoms arise, with overt jaundice [direct bilirubin], evidence of mitochondrial toxicity, ALT >10 times ULN, ALT at lower levels if newly marketed agent; important to rule out other causes; problematic agents include didanosine, stavudine and zidovudine, nevirapine and efavirenz, full dose ritonavir and tipranavir). 18090386
Hammer SM, Eron JJ Jr, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al.; International AIDS Society-USA. Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA 2008; 300: 555-70. (Updated recommendations on use of antiviral therapy in adults with HIV infection including use of recently approved agents: raltegravir, maraviroc and etravirine). 18677028
Vitezica ZG, Milpied B, Lonjou C, Borot N, Ledger TN, Lefebvre A, Hovnanian A. HLA-DRB1*01 associated with cutaneous hypersensitivity induced by nevirapine and efavirenz. AIDS 2008; 22: 540-1. (Among 21 HIV infected patients treated with nevirapine [n=14] or efavirenz [n=7], 6 developed a hypersensitivity rash, 5 of whom had DRB1*01 compared to 1 [7%] control). 18301070
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 7 were attributed to antiretroviral agents, 2 nevirapine, 1 efavirez and 4 miscellaneous combinations). 18955056
Ingiliz P, Benhamou Y. Elevated liver enzymes in HIV monoinfected patients on HIV therapy: what are the implications? J HIV Ther 2009; 14: 3-7. (Review of the causes of serum enzyme elevations during antiretroviral therapy; nonnucleoside reverse transcriptase inhibitors are capable of causing a hypersensitivity reaction with liver injury arising during the first 6 weeks of therapy, as well as an immunologically mediated injury that arises 6-12 months after starting treatment). 19731558
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 3 antiretroviral agents were among the top 40 cases, including zidovudine [8th, 106 cases], lamivudine [26th, 45 cases] and nevirapine [36th, 37 cases]). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, 4 of which were due to antiretroviral agents, including 3 to combinations with stavudine and 1 to abacavir). 20949552
Li ZC, Li HJ, Dai LL, Gao YQ, Cai WP, Li HY, Huang XJ, et al. Liver injury in HIV-1-infected patients receiving non-nucleosides reverse transcriptase inhibitors-based antiretroviral therapy. Chin Med J (Engl) 2010; 123: 3587-90. (Among 75 Chinese patients on antiretroviral therapy with nevirapine or efavirenz, 45 developed abnormal liver tests, most of which were transient and mild, and risk factors included HBV or HCV coinfection, use of nevirapine and exposure to other hepatotoxic agents). 22166636
Yimer G, Ueda N, Habtewold A, Amogne W, Suda A, Riedel KD, Burhenne J, et al. Pharmacogenetic & pharmacokinetic biomarker for efavirenz based ARV and rifampicin based anti-TB drug induced liver injury in TB-HIV infected patients. PLoS One 2011; 6: e27810. (Among 353 patients with both tuberculosis and HIV infection treated with efavirenz based antiretroviral therapy and four drugs for tuberculosis, ALT elevations above twice normal occurred in 30% during the first 56 weeks of treatment and were associated with female sex, higher efavirenz levels, and slow NAT2 acetylation genotype and ABC B1 3435TT genotype). 22162992
Pineda JA, Neukam K, Mallolas J, López-Cortés LF, Cartón JA, Domingo P, Moreno S, et al. Hepatic safety of efavirenz in HIV/hepatitis C virus-coinfected patients with advanced liver fibrosis. J Infect 2012; 64: 204-11. (Among 189 patients with HIV-HCV coinfection starting on efavirenz based antiretroviral therapy, 12 [6%] developed ALT elevations above 5 times ULN and rates were similar in those with advanced fibrosis or cirrhosis [5.2%], as in those without [6.8%]). 22138553
Neukam K, Mira JA, Ruiz-Morales J, Rivero A, Collado A, Torres-Cornejo A, Merino D, et al; SEGURIDAD HEPÁTICA Study Team of the Grupo HEPAVIR de la Sociedad Andaluza de Enfermedades Infecciosas (SAEI). Liver toxicity associated with antiretroviral therapy including efavirenz or ritonavir-boosted protease inhibitors in a cohort of HIV/hepatitis C virus co-infected patients. J Antimicrob Chemother 2011; 66: 2605-14. (Among 262 patients with HIV-HCV coinfection started on antiretroviral therapy, 20 [7.6%] developed ALT elevations above 5 times ULN with no difference in rates between those with [7%] and without [8%] advanced fibrosis, treated with efavirenz [7%] or protease inhibitor [8%] based therapy). 21903660
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N; Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 children with suspected drug induced liver injury in the US, none were attributed to an antiretroviral agent). 21788760
Daar ES, Tierney C, Fischl MA, Sax PE, Mollan K, Budhathoki C, Godfrey C, et al.; AIDS Clinical Trials Group Study A5202 Team. Atazanavir plus ritonavir or efavirenz as part of a 3-drug regimen for initial treatment of HIV-1. Ann Intern Med 2011; 154: 445-56. (Among 1848 patients treated with either efavirenz or atazanavir /ritonavir in combination with nucleoside analogues, ALT elevations occurred in 2% and at a similar rate in both groups ). 21320923
Yimer G, Amogne W, Habtewold A, Makonnen E, Ueda N, Suda A, Worku A, et al. High plasma efavirenz level and CYP2B6*6 are associated with efavirenz-based HAART-induced liver injury in the treatment of naïve HIV patients from Ethiopia: a prospective cohort study. Pharmacogenomics J 2012; 12: 499-506. (Among 261 patients with HIV infection and low CD4 counts started on 1 of 3 efavirenz based regimens, 41 [16%] developed liver injury, usually within 8 weeks, 11 cases were considered severe, but only 2 required change in regimen; statistical association found with CYP 2B6 polymorphisms). 21862974
Mankhatitham W, Lueangniyomkul A, Manosuthi W. Hepatotoxicity in patients co-infected with tuberculosis and HIV-1 while receiving non-nucleoside reverse transcriptase inhibitor-based antiretroviral therapy and rifampicin-containing anti-tuberculosis regimen. Southeast Asian J Trop Med Public Health 2011; 42: 651-8. (Among 134 patients with HIV infection and tuberculosis treated with rifampin, ALT elevations > 5 times ULN occurred in 3 patients on nevirapine [4.6%] and 1 [1.4%] on efavirenz) . 21706943
Qayyum S, Dong H, Kovacic D, Sohail S, Waters B, Thornton C, Corbett CE. Combination therapy efavirenz/emtricitabine/tenofovir disoproxil fumarate associated with hepatic failure. Curr Drug Saf 2012; 7: 391-3. (41 year old man developed acute liver failure 3 months after starting the combination of efavirenz, emtricitabine and tenofovir). 23373554
Mugusi S, Ngaimisi E, Janabi M, Minzi O, Bakari M, Riedel KD, Burhenne J, et al. Liver enzyme abnormalities and associated risk factors in HIV patients on efavirenz-based HAART with or without tuberculosis co-infection in Tanzania. PLoS One 2012; 7: e40180. (Among 473 patients with HIV infected started on efavirenz, 37 [7.8%] developed ALT or AST values above twice normal during the first 48 weeks of treatment, rates were higher in those with anti-HCV [Hazard ratio = 4.9] and with the CYP 2B6 defective variant allele 2B6*6 [2.5], but not in those with concurrent tuberculosis or with variants of ABC B1, CYP 3A5, or SLCO 1B1). 22808112
Chu KM, Manzi M, Zuniga I, Biot M, Ford NP, Rasschaert F, Zachariah R. Nevirapine- and efavirenz-associated hepatotoxicity under programmatic conditions in Kenya and Mozambique. Int J STD AIDS 2012; 23: 403-7. (Among 5832 African patients starting nevirapine or efavirenz based antiretroviral therapy for HIV infection, 124 [2.4%] developed ALT or AST elevations >5 times ULN, mostly within the first 6 months; mortality rates were the same in patients with [5.7%] and without [5.2%] liver enzyme abnormalities). 22807533
Macías J, Neukam K, Mallolas J, López-Cortés LF, Cartón JA, Domingo P, Moreno S, et al; COINS Study Team. Liver toxicity of initial antiretroviral drug regimens including two nucleoside analogs plus one non-nucleoside analog or one ritonavir-boosted protease inhibitor in HIV/HCV-coinfected patients. HIV Clin Trials 2012; 13: 61-9. (Among 745 Spanish patients with HIV infection started on antiretroviral therapy [with 0.8-3 years of follow up], hepatotoxicity requiring discontinuation occurred in 13% on nevirapine, 4% on efavirenz, and 6% on protease inhibitors). 22510353
Nelson M, Amaya G, Clumeck N, Arns da Cunha C, Jayaweera D, Junod P, Li T, Tebas P, et al.; ECHO and THRIVE Study Groups. Efficacy and safety of rilpivirine in treatment-naive, HIV-1-infected patients with hepatitis B virus/hepatitis C virus coinfection enrolled in the Phase III randomized, double-blind ECHO and THRIVE trials. J Antimicrob Chemother 2012; 67: 2020-8. (Pooled analysis of 2 controlled trials of rilpivirine vs efavirenz in HIV/HBV [n=55] and HIV/HCV [n=57] coinfected patients; ALT elevations occurred in 11.1% on rilpivirine vs 10.6% on efavirenz in coinfected compared to 1.1% vs 1.9% in noncoinfected patients; one case of acute hepatitis in each group; discontinuations for hepatic adverse events were reported in 3 rilpivirine vs 9 efavirenz treated subjects). 22532465
Cohen CJ, Molina JM, Cahn P, Clotet B, Fourie J, Grinsztejn B, Wu H, et al.; ECHO Study Group; THRIVE Study Group. Efficacy and safety of rilpivirine (TMC278) versus efavirenz at 48 weeks in treatment-naï HIV-1-infected patients: pooled results from the phase 3 double-blind randomized ECHO and THRIVE Trials. J Acquir Immune Defic Syndr 2012; 60: 33-42. (Pooled analysis of 3 controlled trials of 48 weeks of rilpivirine [n=686] vs efavirenz [n=682] in HIV infection; efficacy was similar, but adverse events were fewer with rilpivirine, including lower rates of grade 2 ALT elevations [5% vs 8%]; no mention of clinically apparent liver injury). 22343174
Wilkin A, Pozniak AL, Morales-Ramirez J, Lupo SH, Santoscoy M, Grinsztejn B, Ruxrungtham K, et al.; TMC278-C204 Study Group. Long-term efficacy, safety, and tolerability of rilpivirine (RPV, TMC278) in HIV type 1-infected antiretroviral-naive patients: week 192 results from a phase IIb randomized trial. AIDS Res Hum Retroviruses 2012; 28: 437-46. (Analysis of efficacy and safety of extended therapy [192 weeks] with rilpivirine [n=279] vs efavirenz [n=89] with 2 nucleoside analogues; ALT elevations occurred in 6% of both groups, mostly during the first 48 weeks of therapy; no mention of clinically apparent liver injury). 21902621
Van Welzen B, Mudrikova T, Arends J, Hoepelman A. No increased risk of hepatotoxicity in long-term use of nonnucleoside reverse transcriptase inhibitors in HIV-infected patients. HIV Med 2012; 13: 448-52. (Rates of hepatotoxicity were similar in patients on nevirapine or efavirenz based [14.8%] as on protease inhibitor-based [18.5%] antiretroviral regimens; abnormalities occurring mostly during the first year and the major risk factor being HCV coinfection). 22413955
Elsharkawy AM, Schwab U, McCarron B, Burt AD, Daly AK, Hudson M, Masson S. Efavirenz induced acute liver failure requiring liver transplantation in a slow drug metaboliser. J Clin Virol 2013; 58: 331-3. (42 year old woman with HIV infection developed acute liver failure 5 months after switching to efavirenz based antiretroviral therapy [bilirubin initially normal rising to 27.8 mg/dL, ALT 517 rising to 3000 U/L, Alk P 229, INR 3.8], undergoing successful liver transplantation and retrospective testing demonstrating CYP 2B6/*6 and UGT 2B7*2 alleles, both associated with slower metabolism of efavirenz). 23763943
Padmapriyadarsini C, Bhavani PK, Tang A, Kumar H, Ponnuraja C, Narendran G, Hannah E, et al. Early changes in hepatic function among HIV-tuberculosis patients treated with nevirapine or efavirenz along with rifampin-based anti-tuberculosis therapy. Int J Infect Dis 2013; 17: e1154-9. (Among 168 patients with tuberculosis and HIV infection started on an efavirenz or nevirapine based regimen in addition to antituberculosis drugs, there were few differences in median changes in ALT, AST and Alk P, but two patients on efavirenz developed ALT elevations and jaundice). 24120216
Fink DL, Bloch E. Liver transplantation for acute liver failure due to efavirenz hepatotoxicity: the importance of routine monitoring. Int J STD AIDS 2013; 24: 831-3. (26 year old woman developed jaundice 6 months after starting fixed dose regimen of efavirenz, emtricitabine and tenofovir [bilirubin 6.9 mg/dL, AST 1118 U/L, INR 1.6], progressing to acute liver failure and undergoing successful liver transplant). 23970595
Echenique IA, Rich JD. EFV/FTC/TDF-associated hepatotoxicity: a case report and review. AIDS Patient Care STDS 2013; 27: 493-7. (40 year old woman with HIV infection developed ALT elevations 7 months after starting a fixed dose combination of efavirenz, emtricitabine and tenofovir [bilirubin not given, ALT 442 U/L, Alk P 451 U/L], improving within weeks of stopping). 23937548
Usach I, Melis V, Peris JE. Non-nucleoside reverse transcriptase inhibitors: a review on pharmacokinetics, pharmacodynamics, safety and tolerability. J Int AIDS Soc 2013; 16: 1-14. (Review of NNRTIs mentions that delavirdine has extensive hepatic metabolism and its major side effect is skin rash, which is usually transient, but can be severe and lead to Stevens Johnson syndrome; no discussion of hepatotoxicity or ALT elevations). 24008177
Casado JL. Liver toxicity in HIV-infected patients receiving novel second-generation nonnucleoside reverse transcriptase inhibitors etravirine and rilpivirine. AIDS Rev 2013; 15: 139-45. (Among 1368 patients with HIV infection in combined analyses of two controlled trials, ALT elevations above 5 times ULN occurred in 0.2% of rilpivirine vs 2% of efavirenz treated monoinfected, but in 16.7% of both groups in coinfected subjects). 24002197
Manosuthi W, Sukasem C, Lueangniyomkul A, Mankatitham W, Thongyen S, Nilkamhang S, Manosuthi S, et al. CYP2B6 haplotype and biological factors responsible for hepatotoxicity in HIV-infected patients receiving efavirenz-based antiretroviral therapy. Int J Antimicrob Agents 2014; 43: 292-6. (Among 134 Thai adults with HIV infection started on antiretroviral therapy with efavirenz, tenofovir and emtricitabine, 17% developed ALT elevations during the first 24 weeks, but none were above 5 times ULN and there were no associations with specific CYP 2B6 haplotypes which nevertheless were associated with efavirenz drug levels and to a lesser extent Alk P elevations). 24359841
Drugs for HIV infection. Treat Guidel Med Lett 2014: 12: 7-16. (Concise review of the agents available for therapy of HIV infection with listing of doses, side effects, drug-drug interactions and costs; does not list hepatotoxicity among adverse effects of efavirenz). 24457549
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 5 of which were due to antiretroviral agents including lamivudine, zidovudine and nevirapine, but none were attributed to efavirenz). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 cases [1.3%] were attributed to antiretroviral medications, inluding 5 due to nonnucleoside reverse transcriptase inhibitors: nevirapine [2], efavirenz [2] and etravirine [1]). 25754159
Sonderup MW, Wainwright H, Hall P, Hairwadzi H, Spearman CW. A clinicopathological cohort study of liver pathology in 301 patients with human immunodeficiency virus/acquired immune deficiency syndrome. Hepatology 2015; 61: 1721-9. (Among 301 patients with HIV infection who underwent liver biopsy at a South African referral center between 2000 and 2013, 127 [42%] were considered indicative of drug induced liver injury, the agents most commonly being used were TMP/SMZ [67%], antituberculosis agents [32%], fluconazole [7%], herbal medications [6%] and antiretrovirals [61%]; efavirenz was associated with two histologic patterns: a nonspecific hepatitis and submassive necrosis). 25644940
Patil R, Ona MA, Papafragkakis H, Carey J, Moshenyat Y, Alhaddad A, Anand S. Acute liver toxicity due to efavirenz/emtricitabine/tenofovir. Case Reports Hepatol 2015; 2015: 280353. (24 year old man with HIV infection developed abdominal pain 2 months after switching his antiviral regimen to efavirenz, tenofovir and emtricitabine [bilirubin 0.6 mg/dL, ALT 1793 rising to 5346 U/L, Alk P 107 U/L, INR 1.4], yet these values fell by more than half within 7 days of stopping, and he later tolerated tenofovir and emtricitabine with rilpivirine without recurrence). 26161275
Sonderup MW, Maughan D, Gogela N, Setshedi M, Wainwright H, Meintjes G, Spearman W. Identification of a novel and severe pattern of efavirenz drug-induced liver injury in South Africa. AIDS 2016; 30(9): 1483-5. (Among 81 patients with suspected efavirenz hepatotoxicity, had a median time to onset of 20 weeks, skin rash was uncommon and fatality rate was 11%; among 71 patients who had a liver biopsy, half had submassive necrosis [which was associated with higher ALT and bilirubin levels and a more severe course], 30% had mixed hepatitis and the remainer nonspecific hepatitis). 26959511
Wu PY, Cheng CY, Liu CE, Lee YC, Yang CJ, Tsai MS, Cheng SH, et al. Multicenter study of skin rashes and hepatotoxicity in antiretroviral-naïve HIV-positive patients receiving non-nucleoside reverse-transcriptase inhibitor plus nucleoside reverse-transcriptase inhibitors in Taiwan. PLoS One 2017; 12: e0171596. (Among 2341 patients with HIV infection who started antiretroviral therapy with an NNRTI with tenofovir and emtricitabine, 5% developed ALT elevations above 3 times ULN within the first 4 weeks, including 7% on nevirapine, 4% on efavirenz and 4% on rilpivirine; factors most strongly associated with the ALT elevations were HCV and HBV coinfection; no details regarding jaundice, symptoms or outcomes). 28222098

## OTHER REFERENCE LINKS

1. Recent References on Efavirenz: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Efavirenz/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Efavirenz: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Efavirenz)